# Albendazole

## OVERVIEW

### Introduction

Albendazole is an anthelmintic agent used predominantly in treatment of echinococcosis, a parasitic worm that causes cysts in liver and lung. Albendazole therapy is commonly associated with mild and transient serum enzyme elevations and rarely can lead to clinically apparent acute liver injury.

### Background

Albendazole (al ben' da zole) is a benzimidazole anthelmintic agent similar in structure and mechanism of action to thiabendazole and mebendazole and the veterinary agent fenbendazole. The benzimidazoles act by selective binding to beta-tubulin of parasitic worms, causing their immobilization and death. Albendazole has proven efficacy against several parasitic worms and was approved for use in the United States in 1996. Current indications for albendazole include echinococcosis, cysticercosis and strongyloidiasis, against which it is more effective than mebendazole (largely because it is better absorbed). Albendazole is also used for hookworm, whipworm and pinworm infestations. Albendazole is available in tablets of 200 mg generically and under the trade name of Albenza. The dose and duration of albendazole therapy varies by indication, being a single dose of 400 mg orally for minor infestations (which can be repeated a few weeks later), and 400 mg twice daily for 1 to 2 weeks or longer for more serious systemic infections. Albendazole is generally well tolerated; side effects include gastrointestinal upset, dizziness, headaches and hair loss. Uncommon, but potentially severe adverse reactions include bone marrow suppression, pancytopenia, granulocytopenia, sudden worsening of neurocysticercosis, hypersensitivity reactions, rash, erythema multiforme and Stevens Johnson syndrome.

### Hepatotoxicity

Albendazole therapy has been associated with transient and asymptomatic elevations in serum aminotransferase levels in up to 50% of patients treated for more than a few weeks. These abnormalities rapidly improve with stopping therapy which is rarely required (~4%). Albendazole has also been associated with rare instances of clinically apparent liver injury. The onset of injury has been within a few days to as long as 2 months of starting therapy or more rapidly with multiple courses of treatment. The injury can also arise 1 to 2 weeks after a short course of albendazole (1 to 3 days). The pattern of serum enzyme elevations is typically hepatocellular or mixed. Allergic features (rash, fever, eosinophilia) may be present but are not prominent. Most cases have been mild to moderate in severity, and recovery is distinctively rapid once the drug is stopped. However, severe and even fatal cases of albendazole induced liver injury have been reported. Rapid recurrence with rechallenge has been reported but with similar severity. Cases with acute liver failure leading to emergency liver transplantation or death have also occurred.

Likelihood score: B (highly likely cause of clinically apparent liver injury).

### Mechanism of Injury

Albendazole acts by binding tubulin in parasitic worms which it does with greater avidity than the tubulin in mammalian cells, but some of the toxicity of the benzimidazoles may be related to this tubulin-binding activity. In most instances of clinically apparent liver injury, hypersensitivity appears to be the cause. A similar cholestatic or mixed hepatitis has been described in dogs receiving fenbendazole.

### Outcome and Management

Albendazole is usually well tolerated and the liver injury reported with its use has been mild and self-limited in course. Nevertheless, routine monitoring of serum enzymes is recommended before therapy and every 2 weeks with extended courses of treatment. Patients with acute liver injury attributed to albendazole should avoid repeat exposure as recurrence is common. Cross sensitivity to liver injury with other benzimidazoles (such as mebendazole) has been reported but is not invariable. Switching to another benzimidazole after liver injury should be done with caution and with close monitoring of liver tests. It is probably prudent to switch to another class of anthelmintic agents if therapy is still needed.

Drug Class: Anthelmintic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Albendazole – Generic, Albenza®

DRUG CLASS

Anthelmintic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=albendazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Albendazole | 54965-21-8 | C12-H15-N3-O2-S

## ANNOTATED BIBLIOGRAPHY

References updated: 20 April 2026

Zimmerman HJ. Anthelmintics. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 626-8. (Expert review of hepatotoxicity of anthelmintics written in 1999; albendazole is associated with serum aminotransferase elevations in 20% of patients and has been linked to rare instances of acute liver injury).
Keiser J, McCarthy J, Hotez PJ. Chemotherapy of helminth infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1001-7. (Textbook of pharmacology and therapeutics).
Morris DL, Smith PG. Albendazole in hydatid disease—hepatocellular toxicity. Trans R Soc Trop Med Hyg 1987; 81: 343-4. (Among 40 patients treated with albendazole for echinococcosis, 6 had ALT elevations [62-970 U/L, Alk P ~360 U/L] and 1 jaundice [bilirubin 5.7 mg/dL], with rapid resolution on stopping; 2 had positive rechallenge). 3617201
Choudhuri G, Prasad RN. Jaundice due to albendazole. Indian J Gastroenterol 1988; 7: 245-6. (30 year old man with echinococcal cyst developed jaundice 2.5 months after starting albendazole [bilirubin 5.6 mg/dL, ALT 320 U/L, Alk P 1.8 times ULN], resolving within 10 days of stopping; positive rechallenge with appearance of jaundice within two days). 3182029
Jagota SC. Jaundice due to albendazole. Indian J Gastroenterol 1989; 8: 58. (Letter in response to Choudhuri and Prasad recommending limiting dose of albendazole to 400 mg twice daily in cycles of 28 days. Reply by authors stresses the elements of hypersensitivity in the case report). 2914724
el-Mufti M, Kamag A, Ibrahim H, Taktuk S, Swaisi I, Zaidan A, Sameen A, et al. Albendazole therapy of hydatid disease: 2-year follow-up of 40 cases. Ann Trop Med Parasitol 1993; 87: 241-6. (Among 40 Egyptian patients with echinococcal cysts treated with albendazole [usually in three 28 day cycles], hepatotoxicity arose in 2 patients [5%], both resolving on discontinuation; details not given, but Alk P said to be unreliable as a marker of liver injury because it is often raised before therapy). 8257234
Gil-Grande LA, Rodriguez-Cabeiro F, Prieto JG, Sanchez-Ruano JJ, Brasa C, Agular L, Garcia-Hoz F, et al. Randomised controlled trial of efficacy of albendazole in intra-abdominal hydatid disease. Lancet 1993; 342: 1269-72. (Among 43 patients treated with albendazole [10 mg/kg/day] for 10-111 days, 27 had ALT elevations during therapy, which were > twice ULN in 21 and >200 U/L in 4; liver biopsies showed “toxic hepatitis” and changes correlated with higher drug levels in liver; no jaundice or clinically apparent injury and all resolved). 7901585
Klion AD, Massougbodji A, Horton J, Ekoué S, Lanmasso T, Ahouissou NL, Nutman TB. Albendazole in human loiasis: results of a double-blind, placebo-controlled trial. J Infect Dis 1993; 168: 202-6. (23 patients with loiasis were treated with albendazole [n=11: 200 mg twice daily] or placebo [n=12] for 21 days; none developed ALT elevations or evidence of liver injury). 8515109
Misra PK, Kumar A, Agarwal V, Jagota SC. A comparative clinical trial of albendazole versus metronidazole in children with giardiasis. Indian Pediatr 1995; 32: 779-82. (Randomized trial of albendazole [400 mg/day for 5 days] vs metronidazole [7.5 mg/kg thrice daily for 5 days] in 64 children with giardiasis; all children were cured and side effects were similar, no differences in biochemical test results). 8617554
Horton RJ. Albendazole in treatment of human cystic echinococcosis: 12 years of experience. Acta Trop 1997; 64: 79-93. (Current dose of albendazole for therapy of echinococcosis is 800 mg daily for ~3 months; serum enzyme elevations occurred in 10-20% of patients, requiring discontinuation in 4%, all cases were reversible, some possibly due to underlying liver cyst disease). 9095290
Molina JM, Chastang C, Goguel J, Michiels JF, Sarfati C, Desportes-Livage I, Horton J, et al. Albendazole for treatment and prophylaxis of microsporidiosis due to Encephalitozoon intestinalis in patients with AIDS: a randomized double-blind controlled trial. J Infect Dis 1998; 177: 1373-7. (Controlled trial of albendazole vs placebo in 8 patients with HIV and E. intestinalis infection; ALT elevations occurred in 1 patient in each group). 9593027
Inkatanuvat S, Suntharasamai P, Vutikes S, Riganti M. Changes of liver functions after albendazole treatment in human gnathostomiasis. J Med Assoc Thai 1998; 81: 735-40. (98 patients with “gnathostomiasis” were given albendazole [800 mg daily] for 14 days; ALT elevations were present in 44% at day 14, 18% at day 28, peak values of 482 U/L, but all were asymptomatic and most returned to normal by 6 months). 9803063
Dunyo SK, Nkrumah FK, Simonsen PE. A randomized double-blind placebo-controlled field trial of ivermectin and albendazole alone and in combination for the treatment of lymphatic filariasis in Ghana. Trans R Soc Trop Med Hyg 2000; 94: 205-11. (Placebo controlled trial of single dose of albendazole, ivermectin or the combination of both in 1425 persons from filariasis-endemic villages; albendazole therapy was associated with a modest but delayed reduction in microfilarial levels; side effects were mild and self-limited and not different from placebo; no mention of jaundice or hepatitis). 10897370
Shenoy RK, Suma TK, John A, Arun SR, Kumaraswami V, Fleckenstein LL, Na-Bangchang K. The pharmacokinetics, safety and tolerability of the co-administration of diethylcarbamazine and albendazole. Ann Trop Med Parasitol 2002; 96: 603-14. (Pharmacokinetic studies of single oral doses of diethylcarbamazine and albendazole reported no drug-drug interactions and no adverse events). 12396323
Matthaiou DK, Panos G, Adamidi ES, Falagas ME. Albendazole versus praziquantel in the treatment of neurocysticercosis: a meta-analysis of comparative trials. PLoS Negl Trop Dis 2008; 2: e194. (Systematic review of efficacy of albendazole versus praziquantel; no differences in rates of adverse events, but no details given). 18335068
Keiser J, Utzinger J. Efficacy of current drugs against soil-transmitted helminth infections: systematic review and meta-analysis. JAMA 2008; 299: 1937-48. (Systematic review of efficacy and safety of albendazole, mebendazole and pyrantel pamoate as therapy of A. Lumbricoides, hookworm and T. Tichiura; albendazole was well tolerated in most studies, no significant adverse events were reported). 18430913
Choi GY, Yang HW, Cho SH, Kang DW, Go H, Lee WC, Lee YJ, et al. Acute drug-induced hepatitis caused by albendazole. J Korean Med Sci 2008; 23: 903-5. (47 year old man developed fever and rash 2 days after single dose of albendazole and 2 days later was jaundiced [bilirubin 2.8 mg/dL, ALT 4,622 U/L, Alk P 40 U/L, INR 1.44]; rapid recovery). 18955802
Jevtić M, Mikić D, Arsić-Komljenović G, Stanković N, Ristanović E, Sjenicić G, Janićijević-Hudomal S. [Adverse effects of longterm, continual administration of high doses of albendazole in the treatment of echinococcal disease]. Vojnosanit Pregl 2008; 65: 539-44. Serbian. (Among 42 patients with echinococcosis treated with albendazole for 4 to 6 months, ALT elevations occurred in 36% and led to discontinuation in 7%, subsequently resolving in all). 18700464
Mikić D, Jevtić M, Arsić-Komljenović G, Ristanović E, Stanković N, Sjenicić G, Janićijević-Hudomal S. [Impossibility of the treatment of inoperable liver multicystic echinococcosis due to adverse reactions to antihelminitics]. Vojnosanit Pregl 2009; 66: 833-9. Serbian. (27 year old with echinococcal cysts developed ALT elevations after 2 months of albendazole therapy [800 mg daily] and did not tolerate praziquantel [rash] leaving no options). 19938764
Amoruso C, Fuoti M, Miceli V, Zito E, Celano MR, De Giorgi A, Nebbia G. [Acute hepatitis as a side effect of albendazole: a pediatric case]. Pediatr Med Chir 2009; 31: 176-8. Italian. (Seven year old girl with pinworms developed jaundice during third course of albendazole [bilirubin 6.4 mg/dL, ALT 2200 U/L, GGT 58 U/L, Alk P 899 U/L], resolving rapidly upon stopping). 19839402
Drugs for parasitic infections. Treat Guidel Med Lett 2013; 11 (Suppl): e1-31. (Brief description of drugs for parasitic infections in adults and children as well as a table of their major side effects: albendazole is the drug of choice for ascariasis, cutaneous larva migrans, pinworm, hookworm, whipworm, trichinellosis, and several less common parasitic infections; side effects include ALT elevations).
Namwanje H, Kabatereine N, Olsen A. A randomised controlled clinical trial on the safety of co-administration of albendazole, ivermectin and praziquantel in infected schoolchildren in Uganda. Trans R Soc Trop Med Hyg 2011; 105: 181-8. (Trial comparing a 7 day course of the combination of albendazole, ivermectin and praziquantel to standard therapy in 235 children with lymphatic filariasis, schistosomiasis or helminthiasis found no differences in efficacy in decreasing egg counts or microfilariae and no change in liver tests). 21353271
Marin Zuluaga JI, Marin Castro AE, Perez Cadavid JC, Restrepo Gutierrez JC. Albendazole-induced granulomatous hepatitis: a case report. J Med Case Rep 2013; 7: 201. (25 year old woman developed jaundice 2 weeks after starting albendazole [bilirubin 13.8 mg/dL, ALT 1649 U/L, Alk P 145 U/L], biopsy showing epithelioid granulomas, resolving within 2 months). 23889970
Gözüküçük R. Albendazole-induced toxic hepatitis: A case report. Turk J Gastroenterol 2013; 24: 82-4. (28 year old man developed abnormal liver tests 20 days after starting albendazole for hydatid cyst disease [bilirubin not given, ALT 968 U/L, Alk P 209 U/L], resolving rapidly upon stopping and recurring within 3 days of restarting albendazole). 23794356
Akhan O, Yildiz AE, Akinci D, Yildiz BD, Ciftci T. Is the adjuvant albendazole treatment really needed with PAIR in the management of liver hydatid cysts? A prospective, randomized trial with short-term follow-up results. Cardiovasc Intervent Radiol 2014; 37(6): 1568-74. (Among 39 patients with hydatid cysts treated with "puncture, aspiration, injection and reaspiration" [PAIR] with or without albendazole, initial success rates were 100%, but recurrence occurred only in those who did not receive albendazole; side effects occurred in 24% of albendazole treated subjects but their nature was not disclosed). 24464258
Sıvgın S, Eser B, Kaynar L, Kurnaz F, Sıvgın H, Yazar S, Cetin M, et al. Encephalitozoon intestinalis: a rare cause of diarrhea in an allogeneic hematopoietic stem cell transplantation (HSCT) recipient complicated by albendazole-related hepatotoxicity. Turk J Haematol 2013; 30: 204-8. (50 year old man with acute leukemia and hematopoietic cell transplant developed liver test abnormalities 5 days after starting albendazole for E. intestinalis [peak bilirubin 0.9 mg/dL, ALT 519 U/L, Alk P 255 U/L], resolving within 2 weeks of stopping). 24385787
Shah C, Mahapatra A, Shukla A, Bhatia S. Recurrent acute hepatitis caused by albendazole. Trop Gastroenterol 2013; 34: 38-9. (Seven year old boy had 4 episodes of jaundice, each arising shortly after a single dose of albendazole [bilirubin 2.3-5.5 mg/dL, ALT 1208-3005 U/L, Alk P 312-314 U/L], resolving within 10 days on each occasion). 23923374
Nandi M, Sarkar S. Albendazole-induced recurrent hepatitis. Indian Pediatr 2013; 50: 1064. (Five year old boy had 4 episodes of jaundice after receiving 2 to 3 days of albendazole [4th episode: bilirubin 11.5 mg/dL, ALT 2720 U/L, Alk P 1247 U/L, INR 1.6], resolving within 2 months of stopping). 24382909
Ben Fredj N, Chaabane A, Chadly Z, Ben Fadhel N, Boughattas NA, Aouam K. Albendazole-induced associated acute hepatitis and bicytopenia. Scand J Infect Dis 2014; 46: 149-51. (26 year old man with hydatic cyst developed jaundice 1 month after starting a second course of albendazole [bilirubin 20 mg/dL, ALT 2454 U/L, Alk P 198 U/L] with bone marrow suppression, resolving within 2 weeks of stopping). 24423162
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin American published between 1996 and 2012, one case [non-fatal] was attributed to mebendazole, but none to albendazole). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to albendazole or any other anthelmintic agent). 25754159
Amado-Diago CA, Gutiérrez-Cuadra M, Armiñanzas C, Arnaíz de Las Revillas F, Gómez-Fleitas M, Fariñas MC. Echinococcosis: A 15-year epidemiological, clinical and outcome overview. Rev Clin Esp (Barc). 2015;215(7):380-4. (Among 76 cases of hydatidosis seen at a Spanish referral hospital over a 15 year period, 94% had liver involvement, 58% men, ages 19 to 91 years, 37% received albendazole [usually with surgery or drainage], no mention of hepatotoxicity). 26119089
Gomez I Gavara C, López-Andújar R, Belda Ibáñez T, Ramia Ángel JM, Moya Herraiz Á, Orbis Castellanos F, Pareja Ibars E, et al. Review of the treatment of liver hydatid cysts. World J Gastroenterol. 2015;21(1):124-31. (Systematic review of the literature on therapy of hydatid cysts concludes that radical surgery with pre- and postoperative albendazole is the "best treatment option"; no discussion of adverse side effects). 25574085
Verdugo Thomas F, Tapia Mingo A, Ramírez Montes D, Oporto Uribe S. Hepatitis tóxica por albendazol [Albendazole-induced toxic hepatitis]. Gastroenterol Hepatol. 2015;38:436-8. (15 year old female was treated with albendazole [400 mg twice daily for 7 days] 4 times over several years, the last time developing jaundice within 10 days of stopping [19.4 mg/dL, ALT 3741 U/L, Alk P 214 U/L, INR 1.9], resolving on no therapy over the next month). 25179365
Bilgic Y, Yilmaz C, Cagin YF, Atayan Y, Karadag N, Harputluoglu MMM. Albendazole induced recurrent acute toxic hepatitis: a case report. Acta Gastroenterol Belg. 2017;80:309-311. (47 year old woman developed jaundice 10 days after receiving a single dose of albendazole for suspected parasitosis [bilirubin 4.3 mg/dL, ALT 1332 U/L, Alk P 159 U/L, INR 1.2], recovering within 2 months and reporting similar liver injury with jaundice after albendazole therapy 4 years previously). 29560698
Aasen TD, Nasrollah L, Seetharam A. Drug-induced liver failure requiring liver transplant: report and review of the role of albendazole in managing echinococcal infection. Exp Clin Transplant. 2018;16:344-347. (38 year old Iraqi woman developed jaundice 6 weeks after starting albendazole [400 mg twice daily] for hydatid cyst disease [bilirubin 5.0 rising to 12.6 mg/dL, ALT 2118 U/L, INR 1.3 rising to 1.7], with progressive worsening hepatic failure and liver transplantation on hospital day 10). 27228108
Moon SY, Baek YH, Lee SW. [Drug induced liver injury by prophylactic administration of albendazole]. Korean J Gastroenterol. 2019;73:360-364. (30 year old Korean woman developed jaundice shortly after starting albendazole [bilirubin 7.2 mg/dL, ALT 2296 U/L, Alk P 162 U/L], resolving within a month of stopping, having had a similar episode with albendazole therapy 8 years previously). 31234627
Asenov Y, Akin M, Ibiş C, Tekant Y, Özden I. Observed or predicted albendazole hepatotoxicity as an indication for a resection procedure in hepatic hydatid disease – a short series of cases. Chirurgia (Bucur). 2019;114:522-527. (Four patients from Turkey with hepatic hydatid disease were treated surgically and did not need anthelmintic therapy; 3 had developed ALT elevations without jaundice when therapy was attempted [initial ALT values 677, 642 and 482 U/L] and the 4 had autoimmune hepatitis diagnosed before therapy). 31511139
Piloiu C, Dumitrascu DL. Albendazole-induced liver injury. Am J Ther. 2021;28:e335-e340. (Two cases from Romania; 22 year old woman developed jaundice within 10 days of starting albendazole [bilirubin 5.2 mg/dL, ALT 1757 U/L, Alk P 150, INR normal] and a 42 year old woman developing jaundice within a few days of starting albendazole [bilirubin 4.1, ALT 2489 U/L, Alk P 146 U/L, INR 2.35], both cases due to self-administration and both resolving within 1-2 months of stopping). 33590990
Dijmărescu I, Guță OM, Brezeanu LE, Dijmărescu AD, Becheanu CA, Păcurar D. Drug-induced hepatitis in children: the experience of a single center in Romania. Children (Basel). 2022;9:1136. (Over a six year period, 40 children with suspected drug induced liver injury were hospitalized in a single medical center in Bucharest, Romania including 22 [55%] due to acetaminophen and 14 [35%] to albendazole which arose in children ages 4 to 13 years, with mean latency of 22 days, mean initial ALT 714 U/L, GGT 80 U/L, and bilirubin 2.7 [range 0.4 to 17.0 mg/dL], all resolving with discontinuation) 36010027
Dragutinović N, Barać A, Stevanović G, Đorđić I, Paglietti B, Micić J, Aleksić E, et al. Acute hepatitis in a paediatric patient: immune-mediated drug-induced liver injury or albendazole-induced autoimmune hepatitis? J Infect Dev Ctries. 2022;16:1660-1663. (Eight year old girl with urticaria and pinworm infection developed nausea and fever 3 days after starting albendazole which resolved on stopping and 20 days later developed nausea and dark urine 3 days after starting mebendazole, laboratory data not provided but she was jaundiced and had complete resolution after stopping the second benzimidazole). 36332223
Liao JM, Zhan Y, Zhang Z, Cui JJ, Yin JY. HLA-targeted sequencing reveals the pathogenic role of HLA-B*15:02/HLA-B*13:01 in albendazole-induced liver failure: a case report and a review of the literature. Front Pharmacol. 2023;14:1288068. (30 year old man developed jaundice while taking albendazole [duration and dose not provided] with bilirubin 9.8 mg/dL, ALT 2202 U/L, Alk P not provided, prothrombin time 14.1 seconds, and recovered within 2 months of stopping; patient had a history of 2 previous episodes of albendazole adverse effects). 38027017
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, 5 [1%] were attributed to albendazole, 1 to mebendazole, 1 to thiabendazole, but none to fenbendazole). 38992407
Beridze M, Beridze D, Mkhatvari T, Mikeladze L, Nakashidze M, Kashibadze K. Drug acute liver failure in children caused by anthelmintic agents (albendazole): treatment strategy. Exp Clin Transplant. 2024;22(Suppl 5):83-89. (Six children, ages 2 to 14 presented between 2018 and 2023 in Batumi, Georgia with acute liver failure due to albendazole usually arising within a few days of starting therapy [peak ALT 1245-3250 U/L, bilirubin 20.6-52.2 mg/dL, INR 1.9-4.6], 2 recovering spontaneously, 2 undergoing liver transplant, and 2 dying). Muana Wilhelm L, Bachmann J, Cornberg M, Wedemeyer H, Heinrich B. Hepatotoxizität durch Albendazol: sichere Alternativen bei Echinokokkosetherapie [Hepatotoxicity due to albendazole: safe alternatives for echinococcosis therapy]. Inn Med (Heidelb). 2025;66:231-235. German. PMID: 39313604 (72 year old man with a large Echinococcal cyst developed abdominal pain and liver injury 6 weeks after starting albendazole [ALT 338 U/L, Alk P 164 U/L, bilirubin not given] with resolution within 19 days of stopping and no recurrence when switched to mebendazole with dose gradually increased to 4 gm daily with total treatment of 20 months and cyst shrinkage). 39498926

## OTHER REFERENCE LINKS

1. Recent References on Albendazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Albendazole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Albendazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Albendazole)